# Lapatinib

## OVERVIEW

### Introduction

Lapatinib is a small molecule inhibitor of several tyrosine kinase receptors involved in tumor cell growth that is used in the therapy of advanced breast cancer and other solid tumors. Lapatinib therapy is associated with transient elevations in serum aminotransferase levels and rare instances of clinically apparent acute liver injury.

### Background

Lapatinib (la pa' ti nib) is a selective inhibitor of two tyrosine kinase receptors which are associated with tumor growth and angiogenesis. Lapatinib has special activity against the epidermal growth factor receptor (EGFR) and the human epidermal group factor receptor-2 (HER2). Tyrosine kinase receptors are often mutated and over expressed in cancer cells, causing unregulated cell growth and proliferation. Lapatinib is one of several tyrosine kinase inhibitors that have been introduced into cancer chemotherapy and are specially directed at molecular abnormalities that occur in cancer cells. Inhibition of these receptors can lead to dramatic reversal of progression the cancer, although the efficacy is sometimes limited by the development of tumor resistance caused by mutations in the kinase. Lapatinib received approval for use in the United States in 2007 for treatment of patients with advanced or metastatic breast cancer whose tumors over express HER2 to be used in combination with capecitabine. Indications have been broadened since then to include its combination with letrozole in women with advanced breast cancer in whom hormonal therapy is indicated. Lapatinib is available in tablets of 250 mg generically and under the brand name Tykerb. The typical dose of lapatinib in combination with capecitabine is 1,250 once daily in cycles of 21 days and when combined wtih letrozole is 1,500 mg given once daily continuously. Side effects include rash, diarrhea, nausea, vomiting, fatigue, hand-foot syndrome and pruritus. Rare, but potentially severe adverse events include interstitial lung disease, cardiovascular complications, hypersensitivity reactions and embryo fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during lapatinib therapy, occurring in up to half of patients. Values greater than 5 times the upper limit of normal (ULN) occur in 2% to 6% of patients but are usually transient and asymptomatic. Dose adjustments or temporary discontinuations are rarely required for liver test abnormalities.

Since its introduction into clinical use, lapatinib has been linked to several cases of clinically apparent acute liver injury. The clinical features of injury have not been well defined, but the onset is usually within 1 to 3 months of starting lapatinib and the pattern of serum enzyme elevations is typically hepatocellular or mixed (Case 1). Sufficent numbers of reports of liver injury have been made to the Food and Drug Administration such that lapatinib is listed as having hepatotoxicity that can be fatal. The frequency of serious liver injury is estimated to be 0.2%, but is likely higher. Immunoallergic and autoimmune features are uncommon, although genetic studies suggest that lapatinib hepatotoxicity is linked to specific HLA alleles. Most instances are self-limited, but several cases of acute liver failure have been reported with tyrosine kinase receptor inhibitors including imatinib, sunitinib, lapatinib, gefitinib and erlotinib. Recurrence of injury is common with reexposure but may not occur upon switching to another kinase receptor inhibitor.

Likelihood score: B (likely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The clinical and genetic findings associated with acute liver injury from the tyrosine kinase receptor inhibitors suggest that it is immune mediated. Lapatinib is metabolized in the liver largely through the CYP 3A4 and CYP 3A5 pathways, and liver injury may be due to production of a toxic or immunogenic intermediate. Genetic analyses have shown a close correlation of lapatinib liver injury with the HLA alleles DQA1*02:01 and DRB1*07:01. In large retrospective analyses of trials of lapatinib in early stage breast cancer, ALT elevations above 5 times ULN occurred in 7.7% of DRB1*07:01 carriers versus 0.5% of controls.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. There does not appear to be cross reactivity of the hepatic injury among the tyrosine kinase receptor inhibitors and, in some situations, switching to another inhibitor may be appropriate. In using lapatinib, other potentially hepatotoxic agents should be avoided.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## CASE REPORT

### Case 1. Acute hepatitis due to lapatinib.

[Modified from: Peroukides S, Makatsoris T, Koutras A, Tsamandas A, Onyenadum A, Labropoulou-Karatza C, Kalofonos H. Lapatinib-induced hepatitis: a case report. World J Gastroenterol 2011; 17: 2349-52. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21633602)]

A 60 year old woman with metastatic, HER2-positive breast cancer was treated with lumpectomy and axillary lymph node dissection followed by local irradiation, several cycles of adjuvant chemotherapy, long term exemestane and a one year course of trastuzumab. She was free of evidence of disease for three years, but then was found to have 3 suspicious nodules on computerized tomography (CT) of the chest. Exemestane was discontinued and she was started on chemotherapy with capecitabine (1000 mg/m2 twice daily) and lapatinib (1250 mg daily). Capecitabine was stopped after 10 days because of diarrhea, and she was maintained on lapatinib alone. Two weeks later and four weeks after starting lapatinib, she developed jaundice with few other symptoms. Physical examination showed hepatomegaly without rash or fever. She denied taking other medications, a previous history of liver disease or jaundice, risk factors for viral hepatitis or excessive alcohol use. Laboratory tests showed a total bilirubin of 4.1 mg/dL, ALT 583 U/L, AST 457 U/L, alkaline phosphatase 348 U/L, GGTP 213 U/L and INR 1.14 (Table). Lapatinib was stopped. Tests for hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound and CT scan showed no evidence of biliary obstruction or hepatic masses. Jaundice deepened for the first 2 weeks after stopping lapatinib. A liver biopsy showed bridging hepatic necrosis and portal inflammation with eosinophils. Thereafter, she began to improve and all liver tests were normal in follow up 3 months later.

#### Key Points

Medication: | Lapatinib (1250 mg daily)
Pattern: | Hepatocellular (R=10)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks
Recovery: | 3 months
Other medications: | Previously, capecitabine, exemestane.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 24 | 120 | 0.8
10 days | Pre | 30 | 110 | 0.7 | Capecitabine stopped
4 weeks | 0 | 583 | 348 | 4.1 | Lapatinib stopped
6 weeks | 2 weeks | 481 | 310 | 11.8 | Liver biopsy
2 months | 1 month | 260 | 318 | 2.7
3 months | 2 months | 229 | 298 | 2.3
4 months | 3 months | 44 | 246 | 0.9
Normal Values | | <45 | <270 | <1.2

#### Comment

A moderately severe acute hepatitis occurred a month after starting lapatinib in a woman with metastatic breast cancer. She was not taking other medications and other causes of liver injury were adequately excluded. Despite stopping lapatinib at the onset of jaundice, she continued to worsen for several weeks, which prompted a liver biopsy that was interpreted as consistent with drug induced liver injury. Recovery was somewhat slow, but complete by 3 months after onset. At the time of this report, there had been no published cases of lapatinib hepatotoxicity. HLA testing was not reported, but subsequent studies have identified the HLA allele DQA1*02:01 as a major risk factor for lapatinib associated hepatotoxicity, the same allele that was linked to ximelagatran related liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lapatinib – Tykerb®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lapatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lapatinib | 231277-92-2 | C29-H26-Cl-F-N4-O4-S | Lapatinib Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 May 2019

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses gefitiinib, erlotinib and crizotinib but not imatinib or lapatinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Medina PJ, Goodin S. Lapatinib: a dual inhibitor of human epidermal growth factor receptor tyrosine kinases. Clin Ther 2008; 30: 1426-47. (Review of chemistry, pharmacology, mechanism of action, clinically efficacy and toxicity of lapatinib, a dual inhibitor of EGFR and HER2, approved for use in patients with advanced breast cancer typically used in combination with capecitabine; common side effects are diarrhea, hand-foot syndrome, nausea, rash and fatigue; no mention of ALT elevations or clinically apparent liver injury). 18803986
Ryan Q, Ibrahim A, Cohen MH, Johnson J, Ko CW, Sridhara R, Justice R, et al. FDA drug approval summary: lapatinib in combination with capecitabine for previously treated metastatic breast cancer that overexpresses HER-2. Oncologist 2008; 13: 1114-9. (Summary of FDA analyses of trials of lapatinib in breast cancer providing the basis for its approval; ALT elevations occurred in 37% of patients given lapatinib and capecitabine and in a similar proportion given capecitabine alone; clinically apparent liver injury was not mentioned). 18849320
Geyer CE, Forster J, Lindquist D, Chan S, Romieu CG, Pienkowski T, Jagiello-Gruszfeld A, et al. Lapatinib plus capecitabine for HER2-positive advanced breast cancer. N Engl J Med 2006; 355: 2733-43. (In a phase III trial in 324 women with breast cancer, the combination of lapatinib and capecitabine in comparison to capecitabine alone increased progression free survival from 4.1-8.4 months; lapatinib therapy was associated with higher rates of diarrhea, rash and dyspepsia; ALT elevations and clinically apparent liver injury were not mentioned). 17192538
Bekaii-Saab T, Markowitz J, Prescott N, Sadee W, Heerema N, Wei L, Dai Z, et al. A multi-institutional phase II study of the efficacy and tolerability of lapatinib in patients with advanced hepatocellular carcinomas. Clin Cancer Res 2009; 15: 5895-901. (Among 26 patients with hepatocellular carcinoma treated with lapatinib, ALT elevations occurred in 5 [19%], but none were above 5 times ULN and none required dose discontinuation or were associated with clinically apparent liver injury). 19737952
Ramanathan RK, Belani CP, Singh DA, Tanaka M, Lenz HJ, Yen Y, Kindler HL, et al. A phase II study of lapatinib in patients with advanced biliary tree and hepatocellular cancer. Cancer Chemother Pharmacol 2009; 64: 777-83. (Among 57 patients with unresectable hepatobiliary carcinomas treated with one to twelve 28 day cycles of lapatinib, almost half required dose modification and 9% developed ALT elevations >5 times ULN, but none developed clinically apparent liver injury). 19169683
Johnston S, Pippen J Jr, Pivot X, Lichinitser M, Sadeghi S, Dieras V, Gomez HL, et al. Lapatinib combined with letrozole versus letrozole and placebo as first-line therapy for postmenopausal hormone receptor-positive metastatic breast cancer. J Clin Oncol 2009; 27: 5538-46. (Among 219 women with metastatic, HER2 positive breast cancer treated with letrozole with or without lapatinib, progression free survival was improved in those receiving the combination while adverse events were more frequent including hepatobiliary events [8% vs 1%], one of which was fatal in combination arm). 19786658
Tevaarwerk AJ, Kolesar JM. Lapatinib: a small-molecule inhibitor of epidermal growth factor receptor and human epidermal growth factor receptor-2 tyrosine kinases used in the treatment of breast cancer. Clin Ther 2009; 31 Pt 2: 2332-48. (Review of the mechanism of action, pharmacology, efficacy and safety of lapatinib; no discussion of hepatotoxicity). 20110044
Macfarlane RJ, Gelmon KA. Lapatinib for breast cancer: a review of the current literature. Expert Opin Drug Saf 2011; 10: 109-21. (Systematic review of the literature on the efficacy and safety of lapatinib in therapy of breast cancer; hepatotoxicity is not discussed). 21091041
Peroukides S, Makatsoris T, Koutras A, Tsamandas A, Onyenadum A, Labropoulou-Karatza C, Kalofonos H. Lapatinib-induced hepatitis: a case report. World J Gastroenterol 2011; 17: 2349-52. (60 year old woman with breast cancer developed jaundice 2 weeks after starting lapatinib [bilirubin 4.1 mg/dL, ALT 583 U/L, Alk P 348 U/L], biopsy showing bridging necrosis and eosinophils, resolving within 3 months of stopping). 21633602
Spraggs CF, Budde LR, Briley LP, Bing N, Cox CJ, King KS, Whittaker JC, Mooser VE, Preston AJ, Stein SH, Cardon LR. HLA-DQA1*02:01 is a major risk factor for lapatinib-induced hepatotoxicity in women with advanced breast cancer. J Clin Oncol 2011; 29: 667-73. (Genetic analyses in 37 women with breast cancer treated with lapatinib who developed serum ALT elevations during treatment and 286 controls, followed by confirmatory testing of 24 cases and 155 controls identified the HLA allele DQA1*02:01 as present in 71% of cases vs 21% of controls). 21245432
Spraggs CF, Parham LR, Hunt CM, Dollery CT. Lapatinib-induced liver injury characterized by class II HLA and Gilbert's syndrome genotypes. Clin Pharmacol Ther 2012; 91: 647-52. (Genetic analyses on 20 cases of suspected lapatinib hepatotoxicity with jaundice found that 8 had Gilbert syndrome and 14 had HLA-DQA1*02.01 and DRB1*07.01; the absence of the HLA alleles was highly predictive for absence of hepatotoxicity, but its positive predictive value was low). 22357454
Baselga J, Bradbury I, Eidtmann H, Di Cosimo S, de Azambuja E, Aura C, Gómez H, Det al; NeoALTTO Study Team. Lapatinib with trastuzumab for HER2-positive early breast cancer (NeoALTTO): a randomised, open-label, multicentre, phase 3 trial. Lancet 2012; 379 (9816): 633-40. (Among 455 women with HER2-positive breast cancer treated with lapatinib or trastuzumab or both, clinical response rates were similar with the two agents individually, but was greater with the combination; while hepatic adverse events were most frequent with lapatinib, and less with trastuzumab [7.4%], and the combination [9.9%]). 22257673
Castellino S, O'Mara M, Koch K, Borts DJ, Bowers GD, MacLauchlin C. Human metabolism of lapatinib, a dual kinase inhibitor: implications for hepatotoxicity. Drug Metab Dispos 2012; 40: 139-50. (Pharmacokinetic studies in 6 healthy adults showed high intersubject variability, and several of the many intermediates detected were potential reactive metabolites). 21965624
Kaniwa N, Saito Y. Pharmacogenomics of severe cutaneous adverse reactions and drug-induced liver injury. J Hum Genet 2013; 58: 317-26. (Review of genetic studies of severe cutaneous and hepatic adverse events; HLA DQA1*02.01 has been associated with lapatinib hepatotoxicity, mainly in Europeans [Spraggs 2011]). 23635947
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of Tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Thorough review of the hepatotoxicity of 16 tyrosine kinase inhibitors including lapatinib which is associated with ALT elevations in 37-53% of subjects [2-6% above 5 times the ULN] and cases of clinically apparent and fatal liver injury). 23620168
Guan Z, Xu B, DeSilvio ML, Shen Z, Arpornwirat W, Tong Z, Lorvidhaya V, Jiang Z, et al. Randomized trial of lapatinib versus placebo added to paclitaxel in the treatment of human epidermal growth factor receptor 2-overexpressing metastatic breast cancer. J Clin Oncol 2013; 31: 1947-53. (Among 444 women with HER-positive metastatic breast cancer treated with paclitaxel with or without lapatinib, overall survival was improved by the combination [27.8 vs 20.5 months] while adverse events more frequent with lapatinib were diarrhea [77% vs 29%], neutropenia [77% vs 47%] and rash [59% vs 24%]; no mention of ALT elevations or hepatotoxicity). 23509322
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of the use of genetic testing in use of tyrosine kinase inhibitors lapatinib and pazopanib). 23556451
Karczmarek-Borowska B, Sałek-Zań A. Hepatotoxicity of molecular targeted therapy. Contemp Oncol (Pozn) 2015; 19: 87-92. (Review of hepatotoxicity of modern molecular targeted therapies including monoclonal antibodies, protein kinase inhibitors and proteosome inhibitors; lapatinib has an increased risk of liver injury). 26034384
Schaid DJ, Spraggs CF, McDonnell SK, Parham LR, Cox CJ, Ejlertsen B, Finkelstein DM, et al. Prospective validation of HLA-DRB1*07:01 allele carriage as a predictive risk factor for lapatinib-induced liver injury. J Clin Oncol 2014; 32: 2296-303. (Among 1194 women with HER2 positive breast cancer treated with lapatinib, ALT elevations above 5 times ULN occurred in 7.7% of carriers of DRB1*07:01 versus 0.5% of non-carriers). 24687830
Hirasawa M, Hagihara K, Okudaira N, Izumi T. The possible mechanism of idiosyncratic lapatinib-induced liver injury in patients varrying human leukocyte antigen-DRB1*07:01. PLoS One 2015; 10: e0130928. (In silico modeling indicated that lapatinib could modifying the antigen binding groove of HLA-DRB1*07:01 making it more likely to bind antigenic ligands, thus suggesting a mechanism by which lapatinib causes liver injury in the presence of this HLA allele). 26098642
Zhang N, Liu Y, Jeong H. Drug-drug interaction potentials of tyrosine kinase inhibitors via inhibition of UDP-glucuronosyltransferases. Sci Rep 2015; 5: 17778. (Lapatinib was found to inhibit UGT1A1 activity in vitro suggesting that it might cause significant drug-drug interactions with agents metabolized by UGT1A1). 26642944
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents [5.5%], 9 of which were due to kinase inhibitors [6 icteric, none fatal] including 5 from imatinib, 2 lapatinib, 1 regorafenib and 1 cediranib). 25754159
Parham LR, Briley LP, Li L, Shen J, Newcombe PJ, King KS, Slater AJ, et al. Comprehensive genome-wide evaluation of lapatinib-induced liver injury yields a single genetic signal centered on known risk allele HLA-DRB1*07:01. Pharmacogenomics J 2016; 16: 180-5. (Genome wide evaluation of 34 cases of suspected lapatinib hepatotoxicity and 810 controls failed to find any significant association outside of the previously identified HLA-DRB1*07:01 associated polymorphisms and no additional associated individual variants were identified by whole genome sequencing of 26 cases and 19 controls). 25987243
Piccart-Gebhart M, Holmes E, Baselga J, de Azambuja E, Dueck AC, Viale G, Zujewski JA, et al. Adjuvant lapatinib and trastuzumab for early human epidermal growth factor receptor 2-positive breast cancer: results from the randomized phase III adjuvant lapatinib and/or trastuzumab treatment optimization trial. J Clin Oncol 2016; 34: 1034-42. (Among 8381 women with HER2 positive early breast cancer given adjuvant therapy for one year, addition of lapatinib did not improve disease free survival compared to trastuzumab alone and total, serious and dose-modifying adverse events were more frequent with its use including "hepatobiliary" adverse events 3-4% vs 1%, 3 of which were fatal [details not provided]). 26598744
Gómez HL, Neciosup S, Tosello C, Mano M, Bines J, Ismael G, Santi PX, et al. A phase II randomized study of lapatinib combined with capecitabine, vinorelbine, or gemcitabine in patients with HER2-positive metastatic breast cancer with progression after a taxane (Latin American Cooperative Oncology Group 0801 Study). Clin Breast Cancer 2016; 16: 38-44. (Among 142 women with metastatic HER2 positive breast cancer treated with lapatinib combined with either capecitabine, vinorelbine or gemcitabine, overall response rates and progression-free survival were similar in the three groups and ALT elevations occured in 12-40% of patients, which were above 5 times ULN in 4-13%, the highest rates being in those receiving gemcitabine). 26642810
Faulkner L, Meng X, Naisbitt DJ, Spraggs CF, Park BK. No evidence for drug-specific activation of circulating T cells from patients with HLA-DRB1*07:01-restricted lapatinib-induced liver injury. Chem Res Toxicol 2016; 29: 2111-3. (T cells from lapatinib treated patients with and without a history of liver injury during treatment showed no consistent response to in vitro exposure to lapatinib and T cell cloning identified no drug-specific clones). 27989141
Romero Carreño E, Marcos Rodríguez JA, Santana Martínez S, de la Cruz Merino L. [Hepatic toxicity in HER-2(+) breast cancer patient under treatment with capecitabine and lapatinib]. Farm Hosp 2016; 40: 134-6. (31 year old woman with metastatic HER2 positive breast cancer developed liver tests abnormalities while on lapatinib and capecitabine and valproate and levetiracetam for brain metastases [ALT 134 U/L, Alk P 755 U/L, bilirubin 2.3 mg/dL], which improved after stopping valproate and lapatinib, although she was later able to tolerate lapatinib at a lower dose). 26980172
Bunchorntavakul C, Reddy KR. Drug Hepatotoxicity: Newer Agents. Clin Liver Dis 2017; 21: 115-34. (Review of the hepatotoxicity of recently approved medications including the tyrosine kinase inhibitors and lapatinib). 27842767
Petros Z, Makonnen E, Aklillu E. Genome-wide association studies for idiosyncratic drug-induced hepatotoxicity: looking back-looking forward to next-generation innovation. OMICS 2017; 21: 123-31. (Review of genome-wide association studies for idiosyncratic liver injury mentions that lapatinib has been associated with DRB1*07:01 in several large studies). 28253087
Miners JO, Chau N, Rowland A, Burns K, McKinnon RA, Mackenzie PI, Tucker GT, et al. Inhibition of human UDP-glucuronosyltransferase enzymes by lapatinib, pazopanib, regorafenib and sorafenib: implications for hyperbilirubinemia. Biochem Pharmacol 2017; 129: 85-95. (Lapatinib, pazopanib, regorafenib and sorafenb were assessed in vitro for inhibition of UDP-glucuronosyltransferase enzymes and all were found to inhibit UGT1A1-catalyzed bilirubin glucuronidation, perhaps explaining hyperbilirubinemia during therapy with these tyrosine kinase inhibitors). 28065859
Spraggs CF, Parham LR, Briley LP, Warren L, Williams LS, Fraser DJ, Jiang Z, et al. Characterisation of the HLA-DRB1*07:01 biomarker for lapatinib-induced liver toxicity during treatment of early-stage breast cancer patients with lapatinib in combination with trastuzumab and/or taxanes. Pharmacogenomics J 2018; 18: 480-6. (Among 8381 patients with metastatic breast cancer treated with lapatinib or trastuzumab or their combination, ALT elevations above 5 times ULN were more frequent in lapatinib treated subjects and rates were higher in HLA-DRB1*07:01 carriers [homozygous 8.6% and heterozygous 12.9%] vs non-carriers [1.5%], and no such association was found in subjects with elevations treated with trastuzumab alone). 28786423

## OTHER REFERENCE LINKS

1. Recent References on Lapatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lapatinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lapatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lapatinib)